# Disulfiram

## OVERVIEW

### Introduction

Disulfiram is an alcohol deterrent used as an adjunct to treatment of chronic alcoholism, based upon its ability to cause an aversive reaction when taken with alcohol. Disulfiram has been associated with a low rate of with serum aminotransferase elevations during chronic therapy and has been linked to clinically apparent acute liver injury which can be severe and result in fatality.

### Background

Disulfiram (dye sul' fi ram) is tetraethylthiuram disulfide and is a potent inhibitor of aldehyde dehydrogenase activity, which interferes with the oxidative metabolism of alcohol resulting in accumulation of acetaldehyde. The elevations in serum acetaldehyde levels cause the aversive symptoms of disulfiram which include flushing, headache, nausea, vomiting and sweating and can result in dizziness, blurred vision, dyspnea, palpitations, hypotension, chest pain and syncope. Disulfiram was developed as an anthelmintic, but was then pursued as a possible alcohol deterrent when its aversive effects upon alcohol intake were found. Disulfiram was approved for use in the United States in 1948 and has been widely used in management of alcoholism, but in recent years has fallen out of favor because of its difficult side effects. Disulfiram is available in tablets of 250 and 500 mg in generic forms and under the brand name Antabuse. The recommended starting dose is 500 mg once daily for 1 to 2 weeks, followed by a maintenance dose of 125 to 500 mg daily. Treatment can continue for months or years. By itself (without alcohol use), disulfiram has few side effects, but can cause skin rash, gastrointestinal upset, drowsiness, headache, tremor and metallic taste.

### Hepatotoxicity

Chronic therapy with disulfiram is associated with mild serum aminotransferase elevations in up to 25% of patients, but elevations above 3 times the upper limit of normal (ULN) occur in 4% of patients or less. Importantly, disulfiram is a well established cause of clinically apparent liver injury, which can be severe and even fatal. The estimated incidence of acute liver injury is 1 per 10,000 to 30,000 patient-years of disulfiram treatment. The injury usually arises within 2 to 12 weeks of starting disulfiram, but the latency can be shorter in cases of reexposure and may arise only after 3 to 6 months, particularly with intermittent therapy. The clinical presentation resembles acute viral hepatitis and the pattern of injury is typically hepatocellular (Cases 1 and 2). Rash, fever and eosinophilia are not uncommon, but are rarely severe. The injury can be severe (Case 3) and the fatality rate is at least 10% in cases with jaundice. Rechallenge or reexposure is usually associated with rapid recurrence of liver injury and should be avoided. The clinical presentation and histology differ greatly from alcoholic hepatitis, in that disulfiram liver injury is marked by viral hepatitis-like changes of focal hepatocellular necrosis, lobular disarray and chronic inflammatory cell infiltrates with eosinophils, but without significant fat, neutrophils or Mallory bodies. In the 1980s and 1990s, disulfiram was often listed among the most common causes of acute liver injury and liver failure due to medications. More recently, disulfiram use has decreased and cases of clinically apparent liver injury from disulfiram are now rare. The majority of cases of disulfiram hepatotoxicity have been reported from Scandinavian countries.

Chronic therapy with disulfiram can cause widespread homogenous eosinophilic inclusions in hepatocytes, similar to the “ground glass” changes that can occur in chronic HBsAg carriers.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of disulfiram hepatotoxicity is probably idiosyncratic hypersensitivity as suggested by the frequency of immunoallergic features (rash, fever, eosinophilia), the frequency of eosinophilic infiltrates seen on liver biopsy, and the prompt recurrence of enzyme elevation after rechallenge. Disulfiram is metabolized in the liver and is a moderate inhibitor of CYP 2C9, for which reason it can cause significant drug-drug interactions with other agents metabolized by this P450 enzyme.

### Outcome and Management

The severity of liver injury associated with disulfiram can range from asymptomatic elevations in serum aminotransferase levels, to symptomatic liver injury with jaundice, to acute liver failure and death. Disulfiram hepatotoxicity with jaundice is associated with high mortality and appearance of symptoms or signs of liver injury should lead to its immediate discontinuation. If stopped early, complete recovery is expected within 4 to 6 weeks. Rechallenge leads to rapid recurrence and should be avoided. There is no known cross sensitivity to liver injury between disulfiram and other agents used to treated alcohol dependence.

Drug Class: Substance Abuse Treatment Agents

## CASE REPORTS

### Case 1. Acute hepatitis and jaundice arising 30 days after starting disulfiram in an alcoholic patient with chronic hepatitis C.(1)

A 42 year old male with chronic hepatitis C was started on disulfiram for chronic alcohol abuse and lisinopril for hypertension. A few days later, he developed diarrhea and stopped lisinopril. One to two weeks later, he developed fatigue, nausea, vomiting and poor appetite, but he continued taking disulfiram until he developed jaundice 30 days after starting. He sought medical attention 2 days later and was hospitalized for evaluation. He had a history of type 2 diabetes for which he had been taking metformin for several years. He claimed to have had no alcohol intake since starting disulfiram, and an admission serum alcohol level was negative. His chronic hepatitis C (genotype 1, HCV RNA 32, 300 IU/mL) was considered mild and had never been treated. Physical examination showed no fever, rash or signs of chronic liver disease. He was mildly jaundiced. Laboratory tests revealed a total serum bilirubin of 5.9 mg/dL with marked elevations in ALT (1715 U/L) and AST (919 U/L), but normal alkaline phosphatase levels (95 U/L). Tests for hepatitis A and B were negative as were autoantibodies. An abdominal ultrasound showed a normal liver texture and no evidence of biliary obstruction, which was confirmed by magnetic resonance cholangiography. Over the next few days, he began to improve and serum bilirubin was normal one week later. In follow up his symptoms resolved, and serum ALT levels fell to baseline values. Importantly, HCV RNA was undetectable during the acute injury, but reappeared once it had resolved. One year after this episode, he again had detectable serum HCV RNA and ALT levels were mildly elevated. He was subsequently treated with a course of peginterferon and ribavirin and achieved a sustained virological response. In recent follow up, he has had normal serum aminotransferase levels and no detectable HCV RNA.

#### Key Points

Medication: | Disulfiram (500 mg daily)
Pattern: | Hepatocellular (R=41)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 32 days
Recovery: | Uncertain timing
Other medications: | Metformin (3 years), lisinopril (for 1 week, 3 weeks before presentation)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
Pre | Pre | 49 | 52 | 0.9 | HCV RNA 32,300 IU/mL
5 days | 0 | Fatigue, nausea, anorexia
30 days | 0 | Jaundice, disulfiram stopped
32 days | 2 days | 1715 | 95 | 5.9
33 days | 3 days | 1305 | 93 | 5.1 | HCV RNA negative
35 days | 5 days | 1238 | 137 | 5.6
40 days | 10 days | 562 | 109 | 2.0
41 days | 11 days | 406 | 98 | 1.6
1 year | 1 year | 59 | 83 | 0.3 | HCV RNA 385,000 IU/mL
Treated with peginterferon and ribavirin with sustained virological response
4 years | 4 years | 26 | 97 | 0.8 | HCV RNA negative
Normal Values | | <42 | <115 | <1.2

#### Comment

Despite having chronic hepatitis C and alcoholism, the acute injury that began within a month of starting disulfiram was clearly due to this medication rather than HCV or alcoholic hepatic injury. Disulfiram typically causes an acute hepatitis like syndrome 2 to 12 weeks after starting the medication that can be severe and lead to acute liver failure or need for liver transplantation. Alcoholic liver injury can cause jaundice and symptoms, but rarely causes serum aminotransferase elevations above 5 to 8 times the upper limit of normal and AST values are usually higher than ALT values. Chronic hepatitis C can be associated with flares of disease activity, but these are rarely associated with symptoms or jaundice unless cirrhosis is present. Importantly, HCV RNA levels usually increase or are stable during flares of hepatitis C, but fall markedly (and may be below the level of detection as in this example) during acute superimposed forms of liver injury. Note also that the minimal pretreatment and residual, chronic ALT elevations (49 and 59 U/L) resolved once HCV was eradicated [falling to 26 U/L).

### Case 2. Acute liver injury from disulfiram therapy with positive rechallenge.(2)

A 53 year old man with chronic alcoholism was treated with disulfiram as a part of alcohol rehabilitation in a dose of 500 mg daily for 5 days followed by 250 mg daily. After 3 weeks he developed jaundice and disulfiram was stopped. He denied use of alcohol since starting disulfiram. Physical examination revealed jaundice and a mildly enlarged and tender liver without signs of chronic liver disease, fever or rash. Serum total bilirubin was 8.8 mg/dL, AST 950 U/L and alkaline phosphatase 330 U/L. The total white count was normal (8,200/μL) with 4% eosinophils. Liver tests had been normal before starting disulfiram (Table). Tests for hepatitis B were negative. A liver biopsy showed portal inflammation and focal hepatocyte necrosis without fat or Mallory bodies. Over the next month, liver tests returned to normal. Because of the continued desired to use disulfiram to aid alcohol avoidance, the patient was readmitted to the hospital and underwent rechallenge with disulfiram (500 mg daily). Four days later, serum enzymes rose and disulfiram was stopped. Liver test abnormalities fell to normal within 2 weeks.

#### Key Points

Medication: | Disulfiram (250 mg daily)
Pattern: | Hepatocellular (R=5.9)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 21 days initially, 4 days upon rechallenge
Recovery: | 30 days
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
Pre | | 30 | 80 | 0.5 | Admission for rehabilitation
3 weeks | 0 | 950 | 330 | 8.8 | Disulfiram stopped
| 1 day | 1400 | 440 | 9.8
4 weeks | 7 days | 1050 | 410 | 8.0 | Liver biopsy
5 weeks | 17 days | 350 | 205 | 2.8 | Hospital discharge
7 weeks | 4 weeks | 35 | 120 | 0.4
Readmitted for rechallenge
1 day | | 10 | 60 | 0.4 | Disulfiram 500 mg daily
2 days | | 11 | 55 | 0.4
3 days | | 12 | 58 | 0.5
4 days | 0 | 190 | 201 | 1.8 | Disulfiram stopped
5 days | 1 day | 260 | 320 | 2.8
6 days | 2 days | 280 | | 3.2
7 days | 3 days | 440 | 340 | 2.8
8 days | 4 days | 150 | 360 | 3.2
9 days | 5 days | 110 | 350 | 1.8
14 days | 10 days | 40 | 110 | 0.4
Normal Values | | <40 | <85 | <1.2

* Some values estimated from Figure 1.

#### Comment

The onset of acute liver injury within 3 weeks of starting disulfiram, the prompt improvement upon withdrawal (starting in 3 to 5 days) and the reappearance of hepatic injury within a few days of restarting make this a fairly definite case of disulfiram-hepatotoxicity. The order of improvement of liver tests was ALT, followed by bilirubin and then alkaline phosphatase, which is typical of drug induced liver injury.

### Case 3. Severe acute liver injury after disulfiram therapy.(3)

A 28 year old man with chronic alcoholism was started on disulfiram in a dose of 400 mg three times weekly. Seven weeks later, he developed fatigue, nausea, vomiting and abdominal pain followed by jaundice. After several days of symptoms, he sought medical advice and was hospitalized. He denied use of alcohol since starting disulfiram and took no other medications. Physical examination showed jaundice and an enlarged liver, but no signs of chronic liver disease, fever or rash. Serum bilirubin was 9.7 mg/dL, ALT 2632 U/L and alkaline phosphatase 775 U/L. The prothrombin time was prolonged. Tests for hepatitis A, B and C were negative and autoantibodies were not detected. Disulfiram was stopped promptly, but he became increasingly jaundiced and was transferred to a liver transplant center. Although bilirubin had risen to 27.5 mg/dL and the prothrombin index was only 28%, he had no signs or symptoms of hepatic encephalopathy. He was treated with lactulose and vitamin K and began to recover. In follow up, serum liver tests improved although alkaline phosphatase levels remained mildly abnormal. Specialized testing demonstrated presence of antibodies to human CYP 1A2 and rat CYP 3A1, without reactivity to human CYP 2E1, 2C9, 2D6, and 3A4.

#### Key Points

Medication: | Disulfiram (400 mg three times weekly)
Pattern: | Hepatocellular (R=9.5)
Severity: | 4 (jaundice, prothrombin time prolonged)
Latency: | 7 weeks
Recovery: | 2 months for complete resolution
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
0 | 0 | Disulfiram started
1 week | 0 | 16 | | | Nausea
7 weeks | 0 | Worsening symptoms & jaundice, disulfiram stopped
| 5 days | 2632 | 775 | 9.8
9 weeks | 1 week | 2420 | 550 | 27.5 | Prothrombin index 28%
10 weeks | 2 weeks | 1866 | 508 | 35.3 | Albumin 3.1
12 weeks | 4 weeks | 1186 | 608 | 13.4
14 weeks | 6 weeks | 190 | 375 | 4.3
15 weeks | 7 weeks | 82 | 342 | 3.0
17 weeks | 9 weeks | 27 | 258 | 1.5
8 months | 6 months | 21 | 233 | 0.7 | Asymptomatic
Normal Values | | <40 | <345 | <1.2

#### Comment

The presence of antibodies to CYP 1A2 is highly suggestive of drug induced liver disease, as these have also been described in patients with dihydralazine induced hepatitis. The latency of seven weeks and the rapid resolution after stopping are consistent with disulfiram hepatotoxicity. The clinical picture of jaundice with extremely elevated levels of serum ALT and AST is also characteristic for this type of injury, and is associated with a mortality of almost 30%. In this instance, the severity may have been due, at least in part, to the delay in stopping disulfiram which may also have accounted for the delay in improvement.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Disulfiram – Generic, Antabuse®

DRUG CLASS

Substance Abuse Treatment Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Disulfiram)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Disulfiram | 97-77-8 | C10-H20-N2-S4

## CITED REFERENCES

1 Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology.
2 Morris SJ, Kanner R, Chiprut RO, Schiff ER. (1978). Disulfiram hepatitis. Gastroenterology.
3 Eliasson E, Stål P, Oksanen A, Lytton S. (1998). Expression of autoantibodies to specific cytochromes P450 in a case of disulfiram hepatitis. J Hepatol.

## ANNOTATED BIBLIOGRAPHY

References updated: 07 September 2021

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 724-5. (Expert review of hepatotoxicity published in 1999 summarizes 80 cases of disulfiram hepatic injury, 28% of which were fatal; cases were invariably hepatocellular).
Mihic SJ, Koob GF, Mayfield J, Harris RA. Ethanol. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 421-31. (Textbook of pharmacology and therapeutics).
Hald J, Jacobsen E. (1948). A drug sensitizing the organism to ethyl alcohol. Lancet. (Review of the effects of disulfiram after ingestion of alcohol; facial vasodilation, tachycardia, dyspnea, nausea and headache starting 7-12 minutes after ingestion, maximal at 30 minutes and resolving in 3-6 hours, correlating with acetaldehyde levels with no change in rate of alcohol metabolism).
Martensen-Larsen O. (1948). Treatment of alcoholism with a sensitizing drug. Lancet. (Initial clinical study of Antabuse in 83 subjects with alcoholism with promising results in 74; no idiosyncratic side effects mentioned).
Knutsen B. (1949). Tidsskr Nor Laegeforen. (Patient developed rash and jaundice 4 weeks after starting disulfiram therapy progressing to hepatic failure and death).
Keeffe EB, Smith FW. (1974). Disulfiram hypersensitivity hepatitis. JAMA. (44 year old developed fatigue and jaundice 10 days after starting disulfiram [bilirubin 6.9 mg/dL, AST 2040 U/L, minimal Alk P elevation, no eosinophilia], with rapid resolution but recurrence of symptoms, mild jaundice, AST elevations and urticaria within 10 days of restarting).
Fisher AA. (1975). Disulfiram hypersensitivity hepatitis. JAMA. (Letter in response to Keeffe [1974] suggesting that a patch test might help validate hypersensitivity as the cause of the hepatitis due to disulfiram).
Eisen HJ, Ginsberg AL. (1975). Letter: Disulfiram hepatotoxicity. Ann Intern Med. (49 year old developed jaundice 4 weeks after starting a second course of disulfiram [bilirubin 43 mg/dL, ALT 801 U/L, AST 1650 U/L, Alk P 220 U/L], with rapid resolution and recurrence within 4 days of restarting [bilirubin 25 mg/dL, AST 1245 U/L, Alk P 211 U/L, 1% eosinophils]).
Ranek L, Buch Andreasen P. (1977). Disulfiram hepatotoxicity. Br Med J. (Six patients, 4 women and 2 men, ages 38 to 69 years, developed severe hepatitis 3-25 weeks after starting disulfiram [bilirubin 17-83 mg/L, ALT 97-940 U/L, Alk P 62-114 U/L], all developed hepatic failure and 5 died, 4 had delay in stopping drug).
Morris SJ, Kanner R, Chiprut RO, Schiff ER. (1978). Disulfiram hepatitis. Gastroenterology. (53 year old man developed jaundice 21 days after starting disulfiram [bilirubin 8.8 mg/dL, AST 950 U/L, Alk P 80 U/L, 4% eosinophils], resolving in 1 month, recurring on rechallenge after 4 days: Case 2).
Goyer PF, Major LF. (1979). Hepatotoxicity in disulfiram-treated patients. J Stud Alcohol. (Among 35 alcoholic patients given disulfiram and 15 alcoholic controls, there were no difference in AST or Alk P elevations at 3 weeks).
Skomedal T. (1979). Tidsskr Nor Laegeforen.
Vázquez JJ, Pardo-Mindan J. (1979). Liver cell injury (bodies similar to Lafora's) in alcoholics treated with disulfiram (Antabuse). Histopathology. (Three men, ages 35, 55 and 60 years, on long term disulfiram therapy with normal liver tests underwent liver biopsies and were found to have homogenous to granular inclusion bodies in hepatocytes that resembled ground-glass cells or Lafora bodies; changes reflective of proliferation of smooth endoplasmic reticulum).
Kristensen ME. (1981). Toxic hepatitis induced by disulfiram in a non-alcoholic. Acta Med Scand. (49 year old woman with nickel hypersensitivity developed mild symptoms and ALT elevations 8 weeks after starting disulfiram as chelating agent [bilirubin <1.0 mg/dL, ALT 412 U/L, Alk P 444 U/L], with recurrence within 3 days of restarting).
Kobborg N, Søgaard PE. (1981). Ugeskr Laeger.
Holm-Bentzen M, Almbjerg F, Ranek L. (1981). Ugeskr Laeger.
Wise JD. (1981). Disulfiram toxicity--a review of the literature. J Ark Med Soc. (Review of the literature on adverse effects of disulfiram, including hepatotoxicity).
Schade RR, Gray JA, Dekker A, Varma RR, Shaffer RD, Van Thiel DH. (1983). Fulminant hepatitis associated with disulfiram. Report of a case. Arch Intern Med. (31 year old man developed nausea and abdominal pain 6 weeks after starting disulfiram [bilirubin 8 rising to 32 mg/dL, AST 2548 U/L, Alk P 129 U/L], with subsequent worsening, hepatic failure and death; massive hepatic necrosis was present on autopsy).
Vázquez JJ, Diaz de Otazu R, Guillen FJ, Zozaya J, Pardo FJ. (1983). Hepatitis induced by drugs used as alcohol aversion therapy. Diagn Histopathol. (Analysis of 20 liver biopsies from 17 patients on cyanamide or disulfiram as alcohol aversion therapy showed presence of inclusion bodies in cytoplasm of hepatocytes, typically in periportal areas and with scant accompanying inflammation and no clearly associated with symptoms or clinically apparent liver injury).
Kaaber K, Menné T, Veien N, Hougaard P. (1983). Treatment of nickel dermatitis with Antabuse; a double blind study. Contact Dermatitis. (Among 11 women with nickel dermatitis treated with disulfiram, 2 developed liver injury, one being symptomatic).
Nässberger L. (1984). Disulfiram-induced hepatitis--report of a case and review of the literature. Postgrad Med J. (32 year old woman developed rash after 2 months and had abnormal liver tests after 6 months of disulfiram therapy [bilirubin normal, ALT 229 U/L, Alk P 1488 U/L, eosinophils 12%], resolving slowly upon withdrawal).
Nässberger L. (1984). Hepatotoxicity due to disulfiram. J Toxicol Clin Toxicol. (Review of hepatotoxicity from disulfiram indicating that there have been 24 cases reported in the literature with 9 deaths).
Sundkvist T, Johansson B. (1984). Lakartidningen. (47 year old man developed jaundice 6 weeks after starting disulfiram [bilirubin 13.1 mg/dL, ALT 1695 U/L, Alk P 492 U/L], resolving within 4-8 weeks of stopping).
Bartle WR, Fisher MM, Kerenyi N. (1985). Disulfiram-induced hepatitis. Report of two cases and review of the literature. Dig Dis Sci. (2 patients, 30 year old man and 43 year old woman, developed jaundice one month after starting disulfiram [bilirubin 7.3 and 9.8 mg/dL, ALT 2,200 and 2,150 U/L, Alk P 202 and 148 U/L], resolving within 2-4 weeks of stopping and recurring within 1-3 days of restarting).
Nässberger L. (1985). Lakartidningen. (Review of the clinical features, pathogenesis and diagnosis of disulfiram induced liver injury).
Black JL, Richardson JW. (1985). Disulfiram hepatotoxicity: case report. J Clin Psychiatry. (40 year old woman developed fatigue and jaundice 2-3 weeks after starting disulfiram [bilirubin 4.0 mg/dL, AST 942 U/L, Alk P 379 U/L, 6% eosinophils], resolving within 4 weeks of stopping, but followed by relapse to alcohol use).
Nathan RS, Hill SY, Smith L. (1985). Disulfiram and hepatotoxicity. Psychiatr J Univ Ott. (39 year old woman developed fatigue followed by jaundice 2 weeks after starting disulfiram [bilirubin 2.9 mg/dL, ALT 1474 U/L, Alk P 275 U/L, eosinophilia], resolving in 6 weeks of stopping).
Kolupaev GP, Chibisov VA, Iakovlev VA, Lukomskiĭ MI, Petrovich AA. (1986). Sov Med.
Iber FL, Lee K, Lacoursiere R, Fuller R. (1987). Liver toxicity encountered in the Veterans Administration trial of disulfiram in alcoholics. Alcohol Clin Exp Res. (Randomized controlled trial of 12 month course of disulfiram [250 or 1 mg or placebo daily] in 453 alcoholic patients found similar rates of AST, Alk P and bilirubin elevations in the 3 groups, correlating best with alcohol use; 19% having at least 2 elevated AST values).
Barth R, Resnick RH, Smoller B. (1987). Disulfiram and fulminant hepatitis. Dig Dis Sci. (36 year old woman developed jaundice 8 weeks after starting disulfiram, with subsequent progressive liver failure and death [bilirubin 31 mg/dL, AST 1095 U/L, Alk P 333 U/L], autopsy showing massive hepatic necrosis without fibrosis).
Kaaber K, Menne T, Veien NK, Baadsgaard O. (1987). Some adverse effects of disulfiram in the treatment of nickel-allergic patients. Derm Beruf Umwelt. (Among 61 patients with nickel allergy and eczema treated with disulfiram [50-400 mg daily for 4 to 56 days], 11 developed liver test abnormalities of whom 5 had clinically apparent injury, more frequently in elderly, but not dose related).
Friis H, Andreasen PB. (1992). Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med. (Among liver adverse drug reaction reports in Denmark between 1979 and 1987, disulfiram ranked 4th [n=35] in frequency, behind halothane [280], carbamazepine [48], and SMZ-TMP [40], and ahead of valproate [34] and chlorpromazine [24]).
Mach T. (1988). Pol Tyg Lek.
Wright C, Vafier JA, Lake CR. (1988). Disulfiram-induced fulminating hepatitis: guidelines for liver-panel monitoring. J Clin Psychiatry. (52 year old man developed fatigue and pruritus 34 days after starting disulfiram [bilirubin 8.9 rising to 33.4 mg/dL, ALT 2880 U/L, Alk P 222 U/L], with severe course but ultimate recovery).
Berlin RG. (1989). Disulfiram hepatotoxicity: a consideration of its mechanism and clinical spectrum. Alcohol Alcohol. (Review of hepatotoxicity of disulfiram; summarizing 17 reports in the English literature [7 fatal] and suggesting that production of toxic metabolite as the cause).
Cereda JM, Bernuau J, Degott C, Rueff B, Benhamou JP. (1989). Fatal liver failure due to disulfiram. J Clin Gastroenterol. (30 year old man developed jaundice 2 months after starting disulfiram [bilirubin 9.4 mg/dL, ALT 600 U/L], progressing to hepatic failure over the next 3 weeks and death; autopsy showed marked necrosis without cirrhosis).
Mason NA. (1989). Disulfiram-induced hepatitis: case report and review of the literature. DICP. (38 year old woman developed jaundice 4 weeks after starting disulfiram [bilirubin 9.3 mg/dL, ALT 2860 U/L, Alk P not given, 18% eosinophils], disease worsening for 6 days after stopping and then resolving rapidly).
Vanjak D, Samuel D, Gosset F, Derrida S, Moreau R, Soupison T, Soulier A, et al. (1989). Gastroenterol Clin Biol. (44 year old man with cirrhosis developed jaundice 38 days after starting disulfiram with progression to hepatic failure [bilirubin 34.4 mg/dL, ALT 2330 U/L, Alk P 305 U/L, prothrombin index 18%], undergoing successful liver transplant).
Yapa RS. (1989). Danger of Antabuse therapy. Practitioner. (60 year old with cirrhosis developed nausea 2 weeks after starting disulfiram followed by jaundice one week later [bilirubin 11.6 mg/dL, ALT 1998 U/L, Alk P 297 U/L], resolving within 6 weeks of stopping).
Kahn S, Farnum JB, Thomas E. (1990). Disulfiram-induced hepatitis. South Med J. (62 year old woman developed rash, fever, anorexia and pruritus 23 days after starting disulfiram [bilirubin 0.6 mg/dL, ALT 374 U/L, Alk P 197 U/L, 14% eosinophils], resolving within 30 days of stopping).
Knudsen TE, Nielsen-Kudsk JE. (1990). Ugeskr Laeger. (34 year old man developed jaundice 2 months after starting disulfiram [bilirubin 9.1 mg/dL, AST 905 U/L, Alk P 441 U/L], with progression to hepatic failure, coma and death within 3 weeks of presentation).
Phillips M. (1990). Disulfiram-induced fulminating hepatitis and monitoring guidelines. J Clin Psychiatry. (Letter in response to Wright [1988] questioning efficacy of monitoring liver tests in preventing severe outcomes of disulfiram hepatotoxicity and recommending prompt discontinuation at onset of any symptom of liver injury).
Bell H, Raknerud N. (1991). Tidsskr Nor Laegeforen. (49 year old woman developed jaundice 6 weeks after starting disulfiram and 5 days after starting naproxen [bilirubin 26.4 mg/dL, ALT 2815 U/L, prothrombin index 27%], progressing to hepatic failure and death 4 weeks later).
Brewer C. (1992). Controlled trials of Antabuse in alcoholism: the importance of supervision and adequate dosage. Acta Psychiatr Scand Suppl. (Review of efficacy of disulfiram stressing the need for careful surveillance, adequate dosages and compliance monitoring).
Enghusen Poulsen H, Loft S, Andersen JR, Andersen M. (1992). Disulfiram therapy--adverse drug reactions and interactions. Acta Psychiatr Scand Suppl. (Review of Danish adverse effects reports between 1968-81; 53 disulfiram hepatic injury cases found, onset after 16-120 days, 11 fatal; death rate estimated as 1: 25,000 treatment-years).
Wright C, Moore RD, Grodin DM, Spyker DA, Gill EV. (1993). Screening for disulfiram-induced liver test dysfunction in an inpatient alcoholism program. Alcohol Clin Exp Res. (Among 108 patients receiving disulfiram for 4 weeks and 27 controls, any ALT elevations occurred in 25% and were above twice ULN in 4% of patients, compared to 4% and 0% of controls).
Zala G, Schmid M, Bühler H. (1993). Dtsch Med Wochenschr. (49 year old woman developed jaundice 13 days after starting disulfiram [bilirubin 27 mg/dL, ALT 4142 U/L, Alk P 98 U/L], progressing to hepatic failure and death by day 25, autopsy showing massive necrosis without cirrhosis).
Forns X, Caballería J, Bruguera M, Salmerón JM, Vilella A, Mas A, Parés A, et al. (1994). Disulfiram-induced hepatitis. Report of four cases and review of the literature. J Hepatol. (4 cases of disulfiram hepatotoxicity; 3 women and 1 man, ages 25 to 53 years, onset in 5 days to 3 months [bilirubin 9.0-13.2 mg/dL, ALT 825-2500 U/L, Alk P 367-997 U/L], 3 with signs of hepatic failure, delay in stopping in 2 patients, all survived but 2 had evidence of residual injury).
Dupuy O, Flocard F, Vial C, Rode G, Charles N, Boisson D, Flechaire A. (1995). Rev Med Interne. (3 cases of polyneuritis developing in patients on disulfiram without accompanying liver injury).
Kerkhof SC, de Doelder PF, Harinck HI, Stricker BH. (1995). Ned Tijdschr Geneeskd. (3 patients, 2 men and 1 woman, ages 30 to 52 years, developed jaundice 2-5 weeks after starting disulfiram therapy [bilirubin 18.2, 31.6 and 18.8 mg/dL, ALT 1940, 2331, and 3108 U/L, Alk P 131-201 U/L], one dying and others resolving promptly upon stopping).
Saxon AJ, Sloan KL, Reoux J, Haver VM. (1998). Disulfiram use in patients with abnormal liver function test results. J Clin Psychiatry. (Among 57 alcoholic patients starting disulfiram; 32% had ALT elevations at baseline and 27% developed ALT elevations during therapy, but only one developed marked elevations prompting discontinuation [ALT 1200 U/L]).
Carniato A, Fuser R, Vaglia A. (1998). Infez Med. (54 year old woman developed jaundice 40 days after starting disulfiram [bilirubin 12.3 mg/dL, ALT 1641 U/L, GGT 260 U/L, prothrombin index 36%], with slow but ultimately full recovery).
Eliasson E, Stål P, Oksanen A, Lytton S. (1998). Expression of autoantibodies to specific cytochromes P450 in a case of disulfiram hepatitis. J Hepatol. (28 year old man developed jaundice 7 weeks after starting disulfiram [bilirubin 9.8 mg/dL, ALT 2632 U/L, Alk P 775 U/L], with progression to liver failure but ultimate recovery; IgG reactivity found to human CPY 1A2 and rat CYP 3A1 by Western blotting and levels were unchanged 6 months after recovery: Case 3).
Rabkin JM, Corless CL, Orloff SL, Benner KG, Flora KD, Rosen HR, Olyaei AJ. (1998). Liver transplantation for disulfiram-induced hepatic failure. Am J Gastroenterol. (36 year old man developed jaundice and confusion 8 weeks after starting and 2 weeks after stopping disulfiram [bilirubin 7.9 rising to 23.2 mg/dL, ALT 3270 U/L], with progressive hepatic failure ultimately undergoing successful liver transplantation).
Chick J. (1999). Safety issues concerning the use of disulfiram in treating alcohol dependence. Drug Saf. (Review of the adverse effects of disulfiram).
Masiá M, Gutiérrez F, Jimeno A, Navarro A, Borrás J, Matarredona J, Martín-Hidalgo A. (2002). Fulminant hepatitis and fatal toxic epidermal necrolysis (Lyell disease) coincident with clarithromycin administration in an alcoholic patient receiving disulfiram therapy. Arch Intern Med. (47 year old man developed fever, rash and jaundice 1 month after starting disulfiram [bilirubin 15.3 mg/dL, ALT 2603 U/L, Alk P 240 U/L, no eosinophilia, protime 21 seconds], with toxic epidermal necrolysis and subsequent liver failure and death).
Chick J. (2004). Disulfiram: cautions on liver function; how to supervise. Addiction. (Comment on supervision of disulfiram use, fulminant hepatitis being “a rare but real risk”).
Mohanty SR, LaBrecque DR, Mitros FA, Layden TJ. (2004). Liver transplantation for disulfiram-induced fulminant hepatic failure. J Clin Gastroenterol. (16 year old woman developed jaundice 5 weeks after starting disulfiram [bilirubin 23.7 mg/dL, ALT 1852 U/L, Alk P 179 U/L, INR 3.8], undergoing liver transplant 5 days after admission).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, 124 for acetaminophen and 137 for other toxins, the most common being isoniazid [24], propylthiouracil [13], phenytoin [10], valproate [10], amanita [9], nitrofurantoin [7], herbals [7], ketoconazole [6], disulfiram [6], troglitazone [4] and 28 others).
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. (2005). Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol. (Survey of all cases of fatal drug induced liver injury from Swedish Adverse Drug Reporting system from 1966-2002; 103 cases identified as highly probable, probable or possible, disulfiram accounting for 2 cases).
De Valle MB, Av Klinteberg V, Alem N, Olsson R, Björnsson E. (2006). Drug-induced liver injury in a Swedish University hospital out-patient hepatology clinic. Aliment Pharmacol Ther. (Among 1164 patients with liver disease seen over a 10 year period, 77 [6.6%] were suspected cases of drug induced liver injury; disulfiram accounted for 2 cases [3%], ages 38 and 70 years, onset after 42- and 70 days, one jaundiced and both recovered).
Björnsson E, Nordlinder H, Olsson R. (2006). Clinical characteristics and prognostic markers in disulfiram-induced liver injury. J Hepatol. (Analysis of all cases of disulfiram hepatotoxicity from the Swedish Adverse Drug Reactions Advisory Committee from 1979 to 2004; 82 cases, 8 died or had liver transplant, 66% hospitalized, 98% hepatocellular; estimated incidence 1.3 per million prescriptions).
Verge C, Lucena MI, López-Torres E, Puche-Garcia MJ, Fraga E, Romero-Gomez M, Andrade RJ. (2006). Adverse hepatic reactions associated with calcium carbamide and disulfiram therapy: is there still a role for these drugs?. World J Gastroenterol. (4 case reports of hepatotoxicity from alcohol deterrent agents, one due to disulfiram; 48 year old man developed jaundice 1 month after starting disulfiram [bilirubin 27.1 mg/dL, ALT 1288 U/L, Alk P 1.5 times ULN], biopsy showing chronic hepatitis and fibrosis).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, only 1 case was attributed to disulfiram: Case 1).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none to disulfiram or other agents used to treated substance abuse).
Mutschler J, Dirican G, Gutzeit A, Grosshans M. (2011). Safety and efficacy of long-term disulfiram aftercare. Clin Neuropharmacol. (Among 10 patients treated with disulfiram for more than one year, none developed hepatotoxicity and liver enzymes decreased significantly [ALT 65 to 25 U/L, AST 74 to 24 U/L]).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were due to disulfiram).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, one case of which was attributed to disulfiram and was fatal).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 cases [0.5%] were attributed to disulfiram, but none to other medications for alcohol dependence).
Thompson A, Ashcroft DM, Owens L, van Staa TP, Pirmohamed M. (2017). Drug therapy for alcohol dependence in primary care in the UK: a clinical practice research datalink study. PLoS One. (Analysis of a UK Clinical Practice Database from 1990 to 2013 found almost 40,000 patients with newly diagnosed alcohol dependence, only 4677 [11%] of which received pharmacotherapy within the next 12 months, which was predominantly disulfiram in the early 1990s [4.2% to 7.7%] and acamprosate since 2000 [8.3% to 12.3%]).
Baekdal M, Ytting H, Skalshøi Kjær M. (2017). Drug-induced liver injury: a cohort study on patients referred to the Danish transplant center over a five year period. Scand J Gastroenterol. (Among 43 patients with drug induced liver injury seen at a single Danish referral center between 2007 and 2012, the most frequent cause was disulfiram [13 cases, 30%]).
Teschke R. (2018). Top-ranking drugs out of 3312 drug-induced liver injury cases evaluated by the Roussel Uclaf Causality Assessment Method. Expert Opin Drug Metab Toxicol. (The five most commonly implicated agents in drug induced liver disease in an analysis of large published databases with a total of 3312 cases were amoxicillin-clavulanate, flucloxacillin, atorvastatin, disulfiram, and diclofenac).
Ramer L, Tihy M, Goossens N, Frossard JL, Rubbia-Brandt L, Spahr L. (2020). Disulfiram-induced acute liver injury. Case Reports Hepatol. (47 year old non-abstinent woman with alcohol dependence developed nausea, fatigue and abdominal discomfort 11 days after starting disulfiram with subsequent rise of ALT to from 127 U/L when drug was stopped to 1526 U/L without jaundice 28 days later, and then rapidly improving with prednisone therapy).
Goh ET, Morgan MY. (2017). Review article: pharmacotherapy for alcohol dependence – the why, the what and the wherefore. Aliment Pharmacol Ther. (Review of medical therapies for alcohol dependence mentions that disulfiram should be considered a second line drug after acamprosate or naltrexone but is usually well tolerated).
Antonelli M, Ferrulli A, Sestito L, Vassallo GA, Tarli C, Mosoni C, Rando MM, et al. (2018). Alcohol addiction – the safety of available approved treatment options. Expert Opin Drug Saf. (Review of current pharmacologic treatments of alcohol addiction mentions that disulfiram should be avoided in patients with liver disease and is an adversive drug and should not be used in patients who are actively drinking).

## OTHER REFERENCE LINKS

1 Recent References on Disulfiram: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Disulfiram/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Disulfiram: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Disulfiram)